# Abiraterone

## OVERVIEW

### Introduction

Abiraterone is a steroidal antiandrogen used to treat metastatic, castration-resistant prostate cancer. Abiraterone is associated with an appreciable rate of serum enzyme elevation during therapy and with rare but potentially severe instances of acute liver injury with jaundice.

### Background

Abiraterone (a" bir a' ter one) acetate is a semi-synthetic inhibitor of CYP17, a critical enzyme in the pathway of androgen production in the testes and adrenal glands. Abiraterone is used to treat metastatic prostate cancer in men who have undergone castration. The additional inhibition of androgenic steroid synthesis in the adrenals inhibits the growth of the androgen-sensitive prostate cancer cells. Therapy with abiraterone has been shown to prolong relapse-free as well as overall survival in men with metastatic, castration-resistant prostate cancer. Because it acts on another step in the pathway of androgen synthesis and action, abiraterone has been used in combination with agents that block androgen receptors such as enzalutamide and apalutamide, but the combination has not been found to be superior to abiraterone alone. Abiraterone was approved for use in the United States in 2011. It is given in combination with prednisone to prevent hypocorticoidism because abiraterone also inhibits the pathway of cortisol synthesis. In patients who have not undergone orchiectomy, abiraterone should be given in combination with a gonadotropin releasing hormone (GnRH). Abiraterone is available as 250 and 500 mg tablets generically and under the brand name Zytiga. The typical dose is 1000 mg daily in combination with 5 mg of prednisone twice daily. Common side effects include fatigue, nausea, vomiting, diarrhea and abdominal discomfort. Inhibition of CYP17 can also lead to symptoms of mineralocorticoid excess such as hypertension, hypokalemia and fluid retention. Rare but potentially severe adverse events include adrenocortical insufficiency, hypoglycemia in patients with diabetes, increased fractures, embryo-fetal toxicity and hepatotoxicity.

### Hepatotoxicity

Serum aminotransferase elevations occur in up to 13% of patients treated with abiraterone compared with 1% to 8% receiving placebo or a comparator drug, but the abnormalities are generally mild, transient and not associated with symptoms or jaundice. ALT elevations above 5 times the upper limit of normal (ULN) occur in 6% of abiraterone treated vs <1% of placebo treated subjects. While clinically apparent liver injury with jaundice was not reported in the preregistration trials of abiraterone, at least 4 cases of acute liver injury with jaundice were reported after its approval and more widespread clinical use. The clinical features of the liver injury have not been well described, but the latency to onset in reported cases ranged from 4 to 8 weeks and the clinical pattern of illness was acute hepatocellular injury without immune allergic features. Because of the risk of severe acute liver injury with abiraterone therapy, the product label recommends screening for routine liver tests before starting therapy and monitoring of liver tests every 2 weeks for the first 3 months of therapy and monthly thereafter.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of hepatic injury from abiraterone is unknown, but may relate to its mechanism of action in inhibition of CYP17. In addition, abiraterone is metabolized in the liver by the cytochrome P450 system, predominantly CYP 3A4 and 2D6, which may lead to formation of a toxic or immunogenic intermediate. Abiraterone is susceptible to drug-drug interactions with inhibitors, inducers or substrates of the CYP 3A4 or 2D6 microsomal enzymes.

### Outcome and Management

The severity of the liver injury linked to abiraterone therapy has been generally mild, consisting of transient and asymptomatic elevations in serum aminotransferase levels. The product label recommends measuring aminotransferase levels every 2 weeks for 3 months and monthly thereafter and stopping therapy if levels rise above 5 times ULN. Abiraterone should not be restarted unless levels return to normal. Any elevation in ALT in the presence of jaundice or symptoms should lead to permanent discontinuation. Abiraterone has not been linked to cases of chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury between abiraterone and other antiandrogens.

Drug Class: Antineoplastic Agents, Antiandrogens

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES; Abiraterone – Generic, Zytiga®; DRUG CLASS; Antineoplastic Agents; COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Abiraterone); Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Abiraterone | 154229-19-3 | C24-H31-N-O

## ANNOTATED BIBLIOGRAPHY

References updated: 15 March 2023

Abbreviations: LHRH, luteinizing hormone releasing hormone; PSA, prostate specific-antigen.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 before the availability of abiraterone).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam, Elsevier, 2013, p. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; abiraterone is not discussed).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan DP. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, p. 1698. (Textbook of pharmacology and therapeutics).
Danila DC, Morris MJ, de Bono JS, Ryan CJ, Denmeade SR, Smith MR, Taplin ME, et al. (2010). Phase II multicenter study of abiraterone acetate plus prednisone therapy in patients with docetaxel-treated castration-resistant prostate cancer. J Clin Oncol. (Among 58 men with castration-resistant, metastatic prostate cancer who had failed docetaxel treatment and were then treated with abiraterone and prednisone, adverse events included fatigue, nausea, vomiting and diarrhea and 3 patients [5%] had ALT elevations, but none were above 3 times ULN).
Ryan CJ, Shah S, Efstathiou E, Smith MR, Taplin ME, Bubley GJ, Logothetis CJ, et al. (2011). Phase II study of abiraterone acetate in chemotherapy-naive metastatic castration-resistant prostate cancer displaying bone flare discordant with serologic response. Clin Cancer Res. (Among 33 patients with castration-resistant prostate cancer treated with abiraterone and prednisone in continuous 28 day cycles, adverse events were common but usually mild; no mention of ALT elevations or hepatotoxicity).
Fizazi K, Scher HI, Molina A, Logothetis CJ, Chi KN, Jones RJ, Staffurth JN, et al. (2012). COU-AA-301 Investigators. Abiraterone acetate for treatment of metastatic castration-resistant prostate cancer: final overall survival analysis of the COU-AA-301 randomised, double-blind, placebo-controlled phase 3 study. Lancet Oncol. (Among 1195 men with metastatic, castration-resistant prostate cancer enrolled in a controlled trial of abiraterone with prednisone or prednisone alone, both overall and progression free survival were prolonged in the abiraterone arm while side effects were similar in the two groups, including fatigue [9% vs 10%], anemia [8% vs 8%], back pain [7% vs 10%] and abnormal liver tests above 5 times ULN [3.7% vs 3.6%).
Kluetz PG, Ning YM, Maher VE, Zhang L, Tang S, Ghosh D, Aziz R, et al. (2013). Abiraterone acetate in combination with prednisone for the treatment of patients with metastatic castration-resistant prostate cancer: U.S. Food and Drug Administration drug approval summary. Clin Cancer Res. (Summary of clinical results in support of FDA decision to approve abiraterone in combination with prednisone for metastatic, castration-resistant prostate cancer mentions that ALT elevations above 5 times ULN occurred in 6.1% of treated versus 0.7% of control subjects, but that there were no liver related deaths or ALT elevations with jaundice in the preregistration studies [although 2 cases were subsequently reported to the sponsor]).
Rathkopf DE, Smith MR, de Bono JS, Logothetis CJ, Shore ND, de Souza P, Fizazi K, et al. (2014). Updated interim efficacy analysis and long-term safety of abiraterone acetate in metastatic castration-resistant prostate cancer patients without prior chemotherapy (COU-AA-302). Eur Urol. (Among 1088 patients with metastatic, castration-resistant prostate cancer treated with abiraterone and prednisone vs prednisone alone [Fizazi 2012] with further follow up, progression-free but not overall survival was significantly better with abiraterone and side effects included fatigue, back pain, arthralgia, peripheral edema, nausea, constipation and diarrhea; ALT elevations above 5 times ULN occurred in 6% vs 1% of patients and was a cause of some early discontinuations for adverse events).
Caffo O, De Giorgi U, Fratino L, Lo Re G, Basso U, D'Angelo A, Donini M, et al. (2015). Safety and clinical outcomes of patients treated with abiraterone acetate after docetaxel: results of the Italian Named Patient Programme. BJU Int. (Among 265 Italian patients with metastatic, castration-resistant prostate cancer treated with abiraterone and prednisone, overall mean survival was 17 months and toxicity was rarely dose-limiting; 7 patients [2.6%] developed liver toxicity, but none had ALT values above 5 times ULN).
Sternberg CN, Castellano D, Daugaard G, Géczi L, Hotte SJ, Mainwaring PN, Saad F, et al., Abiraterone Global EAP Investigators. (2014). Abiraterone acetate for patients with metastatic castration-resistant prostate cancer progressing after chemotherapy: final analysis of a multicentre, open-label, early-access protocol trial. Lancet Oncol. (Among 2314 patients with metastatic, castration-resistant prostate cancer who participated in a controlled trial and were then enrolled in an early access program and received abiraterone with prednisone for a median of 6 months, 175 [8%] had “grade 3 liver toxicity” but only 13 [1%] had “grade 4”, however, details not provided).
Ryan CJ, Smith MR, Fizazi K, Saad F, Mulders PF, Sternberg CN, Miller K, et al. (2015). COU-AA-302 Investigators. Abiraterone acetate plus prednisone versus placebo plus prednisone in chemotherapy-naive men with metastatic castration-resistant prostate cancer (COU-AA-302): final overall survival analysis of a randomised, double-blind, placebo-controlled phase 3 study. Lancet Oncol. (Among 1088 patients with metastatic, castration-resistant prostate cancer treated with abiraterone and prednisone or prednisone alone, overall survival was slightly longer with abiraterone [34.7 vs 30.3 months] and side effects included mild ALT elevations [13% vs 5%] that were rarely greater than 5 times ULN [0.7% vs 0%]; there were no treatment related deaths).
Houédé N, Beuzeboc P, Gourgou S, Tosi D, Moise L, Gravis G, Delva R, et al. (2015). Abiraterone acetate in patients with metastatic castration-resistant prostate cancer: long term outcome of the Temporary Authorization for Use programme in France. BMC Cancer. (Among 306 patients with metastatic, castration-resistant prostate cancer treated in a French early use program with abiraterone and prednisone, median overall survival was 14.6 months, and 6 patients developed “liver and hepatic” dysfunction; no details provided).
Smith MR, Rathkopf DE, Mulders PF, Carles J, Van Poppel H, Li J, Kheoh T, et al. (2015). Efficacy and safety of abiraterone acetate in elderly (75 years or older) chemotherapy naïve patients with metastatic castration resistant prostate cancer. J Urol. (Among 350 elderly men with metastatic, castration-resistant prostate cancer treated with abiraterone and prednisone vs prednisone alone, both overall and progression-free was higher in the abiraterone treated group and “hepatotoxicity” was greater in the elderly than the younger subjects, being above 5 times ULN in 20.9% vs 9.8% in the treated and 4% and 7.4% in the controls).
Van Praet C, Rottey S, Van Hende F, Pelgrims G, Demey W, Van Aelst F, Wynendaele W, et al. (2016). Abiraterone acetate post-docetaxel for metastatic castration-resistant prostate cancer in the Belgian compassionate use program. Urol Oncol. (Among 368 men with metastatic, castration-resistant prostate cancer treated with abiraterone and prednisone in a Belgian compassionate use program, median overall survival was 15 months and side effects include anemia [14%], hypokalemia [ 7%], fatigue [7%] and liver enzyme elevations [3.5%]; no mention of clinically apparent liver injury).
Sun Y, Zou Q, Sun Z, Li C, Du C, Chen Z, Shan Y, et al. (2016). Abiraterone acetate for metastatic castration-resistant prostate cancer after docetaxel failure: A randomized, double-blind, placebo-controlled phase 3 bridging study. Int J Urol. (Among 214 Chinese patients with metastatic, castration-resistant prostate cancer treated with abiraterone and prednisone or prednisone alone, overall survival was greater with abiraterone and adverse events were “generally similar between the two treatment groups”; ALT elevations occurring in 9.8% on abiraterone and 11.3% on placebo).
Fizazi K, Tran N, Fein L, Matsubara N, Rodriguez-Antolin A, Alekseev BY, Özgüroğlu M, et al. (2017). LATITUDE Investigators. Abiraterone plus prednisone in metastatic, castration-sensitive prostate cancer. N Engl J Med. (Among 1199 men with metastatic, castration sensitive prostate cancer on androgen-deprivation therapy who were treated with abiraterone and prednisone vs placebo, both overall and progression free survival were increased by abiraterone as were serious adverse events [28% vs 24%] and ALT elevations [16% vs 13%] which were above 5 times ULN in 5% vs 1%).
Narita S, Kimura T, Hatakeyama S, Hata K, Yanagisawa T, Maita S, Chiba S, et al. (2022). Real-world outcomes and risk stratification in patients with metastatic castration-sensitive prostate cancer treated with upfront abiraterone acetate and docetaxel. Int J Clin Oncol. (Among 301 patients with metastatic castration-sensitive prostate cancer treated with abiraterone or docetaxel, the progression free survival was longer with abiraterone but overall survival was similar in the two groups, while severe adverse reactions were more frequent with docetaxel [75% vs 18%], except for ALT elevations which rose to above 5 times ULN in 4.9% of recipients of abiraterone).
Colomba E, Marret G, Baciarello G, Lavaud P, Massard C, Loriot Y, Albiges L, et al. (2020). Liver tests increase on abiraterone acetate in men with metastatic prostate cancer: natural history, management and outcome. Eur J Cancer. (Among 25 patients who developed ALT elevations while being treated with abiraterone in a randomized controlled trial [Fizazi et al 2017], peak levels were 1-3 times ULN in 7, 3-5 times ULN in 6, and 5-20 times ULN in 9, resolving in 2 to 14 weeks, half without stopping, 2 of 4 redeveloping ALT elevations upon restarting, but none resulting in jaundice).
Yumiba S, Komori K, Iwanishi T, Koida Y, Kobayashi M, Ono Y. (2017). Hinyokika Kiyo. (77 year old Japanese man with prostate cancer developed fatigue 27 days after starting abiraterone [ALT 420 U/L] and developed progressive worsening within days [ALT rising to 1487 U/L, prothrombin index falling to 23%, Alk P and bilirubin levels not provided] and died of liver failure 2 weeks later).
Singh P, Sinha A, Lama Tamang TG, Chandra AB, Huang YJ. (2018). Abiraterone-associated fulminant liver failure. Am J Ther. (73 year old man with metastatic prostate cancer developed jaundice 7-8 weeks after starting abiraterone [ALT 1800 U/L, AST 1200 U/L, Alk P and bilirubin not provided], with progressive liver failure and death within 2 weeks of onset; in discussion mentions two more cases of clinically apparent liver injury believed to be due to abiraterone reported to the sponsor).
Saad F, Efstathiou E, Attard G, Flaig TW, Franke F, Goodman OB, Oudard S, et al. (2021). ACIS Investigators. Apalutamide plus abiraterone acetate and prednisone versus placebo plus abiraterone and prednisone in metastatic, castration-resistant prostate cancer (ACIS): a randomised, placebo-controlled, double-blind, multinational, phase 3 study. Lancet Oncol. (Among 982 men with metastatic prostate cancer treated with abiraterone [1000 mg with prednisone] with or without apalutamide [240 mg], radiographic progression free survival was longer with combination therapy [22.6 vs 16.6 months], but overall survival was not different [67% vs 69%] and adverse events were more frequent with the combination, including hypertension [17% vs 10%] and ALT elevations [12% vs 4%], but there were no hepatic deaths or mention of clinically apparent liver injury).
Scailteux LM, Despas F, Balusson F, Campillo-Gimenez B, Mathieu R, Vincendeau S, Happe A, et al. (2022). Hospitalization for adverse events under abiraterone or enzalutamide exposure in real-world setting:aA French population-based study on prostate cancer patients. Br J Clin Pharmacol. (Among 11,534 patients newly started on abiraterone or enzalutamide therapy for prostate cancer who were enrolled in the French National Health Insurance System Database between 2013 and 2017, liver test abnormalities were more frequent with abiraterone [17% vs 6%] as were acute kidney injury and atrial fibrillation while “hepatitis” was rare [<0.1%]).
Yanagisawa T, Kimura T, Mori K, Suzuki H, Sano T, Otsuka T, Iwamoto Y, et al. (2022). Abiraterone acetate versus nonsteroidal antiandrogen with androgen deprivation therapy for high-risk metastatic hormone-sensitive prostate cancer. Prostate. (Among 312 men with prostate cancer treated with abiraterone [1000 mg] or bicalutamide [80 mg] daily, overall and cancer specific survival were similar in the two groups, but adverse events were more common with abiraterone [27% vs 21%] as was “impaired liver function” [16% vs 2%], although there were no deaths or severe adverse events attributed to liver injury).

## OTHER REFERENCE LINKS

1 Recent References on Abiraterone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Abiraterone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Abiraterone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Abiraterone)